# Ziprasidone

## OVERVIEW

### Introduction

Ziprasidone is an atypical antipsychotic used in the treatment of adults with schizophrenia and bipolar disorder. Use of ziprasidone has not been consistently associated with serum enzyme elevations but has been linked to rare instances of hypersensitivity reactions accompanied by mild-to-moderate acute liver injury.

### Background

Ziprasidone (zi pras' i done) is a benzisothiazolyl piperazine-type atypical antipsychotic that appears to act as both a dopamine type 2 (D2) and a serotonin (5-HT2) receptor antagonist. It also has moderate activity against α-adrenergic and histamine receptors. Ziprasidone is indicated for the therapy of schizophrenia and as either monotherapy or adjunctive therapy for acute manic episodes and maintenance therapy for manic and mixed episodes in bipolar 1 disorder. Ziprasidone was approved for use in the United States in 2001 and is widely used with more than a million prescriptions written yearly in the United States. Ziprasidone is available as capsules of 20, 40, 60 and 80 mg generically and under the brand name Geodon. It is also available as an oral suspension and as a solution for intramuscular injection. The typical initial dose is 20 mg twice daily, which can be increased to a maintenance dose in the range of 40 to 80 mg twice daily. Common side effects include somnolence, dizziness, restlessness, fatigue, headache, nausea, dyspepsia, anorexia, dry mouth and blurred vision. Weight gain is uncommon and extrapyramidal symptoms occur in about 5% of patients. Uncommon but potentially severe adverse events include neuroleptic malignant syndrome, tardive dyskinesia, rash, DRESS syndrome, metabolic changes with weight gain, hyperglycemia and dyslipidemia, orthostatic hypotension, leukopenia, neutropenia, seizures, suicidal ideation and behaviors, increased risk of cerebral vascular incidents and death in the elderly dementia related psychosis.

### Hepatotoxicity

Liver test abnormalities have been reported in patients taking ziprasidone, but they have not been well characterized in the literature and the frequency of elevations appears to be similar to placebo therapy. Several instances of hypersensitivity reactions have been reported in patients taking ziprasidone, arising within 1 to 4 weeks of starting therapy and with rapid recurrence on reexposure in at least one case. In several instances, the hypersensitivity reaction qualified as DRESS syndrome with rash, eosinophilia and an accompanying liver injury either in the form of moderate serum enzymes or a mixed hepatitis with jaundice. In all instances, the symptoms, signs and laboratory abnormalities resolved rapidly with stopping ziprasidone. Thus, on rare occasions, ziprasidone can cause acute hypersensitivity reactions that can be accompanied by hepatitis, but the liver injury is usually mild and self-limited.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Ziprasidone is largely excreted unchanged in the urine and its hepatic metabolism is minimal, perhaps accounting for why hepatotoxicity is rare. The liver injury caused by ziprasidone is likely due to hypersensitivity and is idiosyncratic in nature. Ziprasidone is less likely to cause weight gain than other atypical antipsychotics and has not been linked to cases of steatosis.

### Outcome and Management

The hypersensitivity reactions to ziprasidone are likely to recur with reexposure and rechallenge should be avoided. Ziprasidone has not been reported to cause acute liver failure, chronic hepatitis or vanishing bile duct syndrome in the published literature. Persons with hypersensitivity to ziprasidone are likely to tolerate other atypical antipsychotic medications, but prospective monitoring is warranted if other such agents are used.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ziprasidone – Generic, Geodon®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ziprasidone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ziprasidone | 122883-93-6 | C21-H21-Cl-N4-O-S

## ANNOTATED BIBLIOGRAPHY

References updated: 10 June 2023

Abbreviations: DRESS, drug reaction with eosinophilia and systemic symptoms.

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Daniel DG, Zimbroff DL, Potkin SG, Reeves KR, Harrigan EP, Lakshminarayanan M. (1999). Ziprasidone 80 mg/day and 160 mg/day in the acute exacerbation of schizophrenia and schizoaffective disorder: a 6-week placebo-controlled trial. Ziprasidone Study Group. Neuropsychopharmacology. (Controlled trial of ziprasidone in two doses [n=210] vs placebo [n=92] for 6 weeks; “Changes in liver enzymes were notably rare.” Three of 210 patients had ALT above 3 times ULN, but these were judged to be unrelated to drug therapy; further characterization not given).
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. (1999). Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry. (Systematic review of 81 articles on weight change with antipsychotics, using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kilograms).
Balestrieri M, Vampini C, Bellantuono C. (2000). Efficacy and safety of novel antipsychotics: a critical review. Hum Psychopharmacol. (Review on efficacy and safety of antipsychotics; 3 of 702 patients on ziprasidone discontinued therapy because of liver test abnormalities).
(2001). Ziprasidone (Geodon) for schizophrenia. Med Lett Drugs Ther. (Brief review of efficacy and safety of ziprasidone shortly after its approval in the US; side effects include somnolence, extrapyramidal symptoms, and transient prolactin elevations; no mention of ALT elevations or hepatotoxicity).
Arato M, O'Connor R, Meltzer HY, ZEUS Study Group. (2002). A 1-year, double-blind, placebo-controlled trial of ziprasidone 40, 80 and 160 mg/day in chronic schizophrenia: the Ziprasidone Extended Use in Schizophrenia (ZEUS) study. Int Clin Psychopharmacol. (Controlled trial of placebo vs ziprasidone in 3 doses in 294 patients; laboratory abnormalities reported in similar proportion of ziprasidone as placebo treated subjects, but details of ALT levels not provided).
Caley CF, Cooper CK. (2002). Ziprasidone: the fifth atypical antipsychotic. Ann Pharmacother. (Review of structure, pharmacology, kinetics, metabolism, efficacy and side effects of ziprasidone; no mention of effects on ALT levels or liver injury).
(2003). Choice of an antipsychotic. Med Lett Drugs Ther. (Common side effects of ziprasidone are insomnia, anxiety, headache, nausea, constipation and lightheadedness; unlike clozapine, olanzapine, risperidone and quetiapine, it has little or no effect on weight; no mention of hepatic side effects).
Prior TI, Baker GB. (2003). Interactions between the cytochrome P450 system and the second-generation antipsychotics. J Psychiatry Neurosci. (Review of the interactions of the atypical antipsychotics with the P450 system; clozapine metabolized by CYP 1A2 and 3A4 and possibly 2C9 and 2D6; risperidone by CYP 2D6 and possibly 3A4; olanzapine by CYP 1A2 and possibly 2D6; quetiapine and ziprasidone by CYP 3A4).
Tsai CF, Tsai SJ, Hwang JP. (2005). Ziprasidone-induced hypersensitivity syndrome in an aged schizophrenia patient. Int J Geriatr Psychiatry. (69 year old Chinese woman developed skin rash and fever 11 days after starting ziprasidone followed by jaundice [bilirubin 4.4 mg/dL, ALT 72 U/L, Alk P 398 U/L, eosinophils 5%], with resolution of all abnormalities within 3 weeks of stopping).
Rettenbacher MA, Baumgartner S, Eder-Ischia U, Edlinger M, Graziadei I, Hofer A, Huber R, et al. (2006). Association between antipsychotic-induced elevation of liver enzymes and weight gain: a prospective study. J Clin Psychopharmacol. (Prospective study of 67 patients started on atypical antipsychotics [6 on ziprasidone]; ALT elevations were more frequent in 14 patients who gained >7% of body weight than in 53 who did not [50% vs 19%], and mean changes in ALT, AST and GGT were greater in those who gained weight; all abnormalities were transient, asymptomatic and not associated with bilirubin elevations).
Wright TM, Vandenberg AM. (2007). Risperidone- and quetiapine-induced cholestasis. Ann Pharmacother. (30 year old man developed jaundice on risperidone and lithium for 8 years [bilirubin 4.7 mg/dL, ALT 99 U/L, Alk P 267 U/L], resolving with change of risperidone to ziprasidone, but recurrent jaundice 1 year later 3 weeks after starting quetiapine, having tolerated olanzapine).
Akkaya C, Sarandol A, Aydogan K, Kirli S. (2007). Urticaria and angio-oedema due to ziprasidone. J Psychopharmacol. (36 year old Turkish woman developed urticaria and facial edema 4 weeks after starting ziprasidone with normal liver tests and no fever, resolving within 3 days of stopping).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; several antidepressants [duloxetine, sertraline, fluoxetine, amitriptyline], but none of the atypical antipsychotic agents were implicated).
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. (2008). Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin; not with aripiprazole, ziprasidone, carbamazepine or lamotrigine).
Parsons B, Allison DB, Loebel A, Williams K, Giller E, Romano S, Siu C. (2009). Weight effects associated with antipsychotics: a comprehensive database analysis. Schizophr Res. (Analysis of weight gain in 21 placebo controlled trials [~3300 patients]; average monthly weight gain in pounds was +0.1 with placebo, +0.8 olanzapine, +0.6 risperidone, -0.3 ziprasidone. A 5% increase in weight occurred after one year in 13% of placebo, 39% haloperidol, 20% ziprasidone, 45% risperidone and 60% olanzapine treated subjects).
Sacchetti E, Galluzzo A, Valsecchi P, Romeo F, Gorini B, Warrington L, MOZART Study Group. (2009). Ziprasidone vs clozapine in schizophrenia patients refractory to multiple antipsychotic treatments: the MOZART study. Schizophr Res. (Controlled trial of clozapine [300 mg] vs ziprasidone [80-160 mg] daily for 18 weeks; similar efficacy; weight gain +0.8 kg with clozapine vs -2.6 kg with ziprasidone; “no detrimental effects for either drug were observed with regard to liver functions…”).
Díaz-Marsá M, Sánchez S, Rico-Villademoros F, ZIP-IIG-79 Study Group. (2009). Effectiveness and tolerability of oral ziprasidone in psychiatric inpatients with an acute exacerbation of schizophrenia or schizoaffective disorder: a multicenter, prospective, and naturalistic study. J Clin Psychiatry. (Open label study in 196 inpatients given ziprasidone; no mention of ALT levels or hepatotoxicity).
Addington DE, Labelle A, Kulkarni J, Johnson G, Loebel A, Mandel FS. (2009). A comparison of ziprasidone and risperidone in the long-term treatment of schizophrenia: a 44-week, double-blind, continuation study. Can J Psychiatry. (Controlled trial of ziprasidone vs risperidone in 139 patients for 8 weeks; less weight gain with ziprasidone; “One ziprasidone-treated patient had an elevation of liver enzymes and was discontinued from the study”).
Kim SW, Shin IS, Kim JM, Bae KY, Yang SJ, Yoon JS. (2010). Effectiveness of switching from aripiprazole to ziprasidone in patients with schizophrenia. Clin Neuropharmacol. (Switching 19 patients with schizophrenia from aripiprazole to ziprasidone resulted in a decline in mean ALT levels [26 to 18 U/L], values becoming normal in 2 of 3 subjects with elevations on aripiprazole).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 4 due to psychotropic agents; one each for quetiapine, nefazodone, fluoxetine and venlafaxine, but none for phenothiazines or ziprasidone).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to perphenazine, but none to ziprasidone).
Gordon JS, Neyman KM, Wells RD, Chen SC. (2012). Drug rash with eosinophilia and systemic symptoms (DRESS syndrome). Cutis. (27 year old woman developed pharyngitis, facial swelling, rash and fever 2 weeks after starting ziprasidone [bilirubin 2.6 mg/dL, ALT 688 U/L, Alk P 812 U/L, eosinophils 19%], with recurrence 2 days after ziprasidone was restarted [bilirubin 11.5 mg/dL, ALT 2061 U/L], responding to high doses of prednisone and then tolerating risperidone).
Marwick KF, Taylor M, Walker SW. (2012). Antipsychotics and abnormal liver function tests: systematic review. Clin Neuropharmacol. (Systematic review of the literature found rates of any serum enzyme elevation during antipsychotic therapy to range from 5-78% and "clinically significant' elevations in 0-15%; lists 1 report of clinically apparent liver injury due to ziprasidone [Tsai 2005]).
Findling RL, Cavuş I, Pappadopulos E, Vanderburg DG, Schwartz JH, Gundapaneni BK, Delbello MP. (2013). Efficacy, long-term safety, and tolerability of ziprasidone in children and adolescents with bipolar disorder. J Child Adolesc Psychopharmacol. (Controlled trial of ziprasidone vs placebo for 4 weeks with a 26 week open label extension study in 237 children or adolescents with bipolar disorder found no "clinically significant mean changes" in liver enzymes).
(2013). Drugs for psychiatric disorders. Treat Guidel Med Lett. (Concise summary of current therapies for psychiatric disorders, mentions that ziprasidone can cause prolongation of QT interval and extrapyramidal symptoms, but does not mention liver injury or ALT elevations).
Kim MS, Kim SW, Han TY, Son SJ, Lee JH, Kim EJ. (2014). Ziprasidone-induced hypersensitivity syndrome confirmed by reintroduction. Int J Dermatol. (33 year old Korean woman developed rash and fever 3 weeks after starting ziprasidone and lithium, with resolution of stopping both and recurrence one day after restarting ziprasidone [ALT 141, atypical lymphocytes 12%], resolving within 2 weeks of stopping).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to chlorpromazine, the only antipsychotic medication listed).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases [0.6%] were attributed to antipsychotic agents, including 3 due to quetiapine and 2 to olanzapine, but none to ziprasidone]).
Mandrioli R, Protti M, Mercolini L. (2015). Evaluation of the pharmacokinetics, safety and clinical efficacy of ziprasidone for the treatment of schizophrenia and bipolar disorder. Expert Opin Drug Metab Toxicol. (Review of the efficacy and safety of ziprasidone does not discuss ALT elevations or hepatotoxicity).
Musil R, Obermeier M, Russ P, Hamerle M. (2015). Weight gain and antipsychotics: a drug safety review. Expert Opin Drug Saf. (Extensive systematic review of the literature on the problem of weight gain during therapy with antipsychotic agents mentions that weight gain of 7% or more occurs in only 4% of patients on ziprasidone and the average weight change is -0.16 to 0.84 kg, rates of weight gain being lower than any other atypical antipsychotic).
Morlán-Coarasa MJ, Arias-Loste MT, Ortiz-García de la Foz V, Martínez-García O, Alonso-Martín C, Crespo J, Romero-Gómez M, et al. (2016). Incidence of non-alcoholic fatty liver disease and metabolic dysfunction in first episode schizophrenia and related psychotic disorders: a 3-year prospective randomized interventional study. Psychopharmacology (Berl). (Among 205 patients started on atypical antipsychotic agents between 2005 and 2012 followed using surrogate markers for fatty liver disease and for fibrosis [Fib-4], 48 [25%] patients developed evidence of fatty liver disease as assessed by FLI, driven largely by weight gain [91%] and increases in waist circumference [69%] and triglycerides [54%]; analysis by specific agent was not provided, most were taking aripiprazole [n=83], risperidone [n=12], quetiapine [n=46] or ziprasidone [50]).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Patel MB, Maddur H. (2017). Elevated levels of AST, ALT, and CPK · no family history of liver disease · Dx?. J Fam Pract. (25 year old man was found to have marked serum enzyme elevations two years after starting valproate and ziprasidone [ALT 334 U/L, AST 1040 U/L, CPK 34,270] and a month after starting a muscle building agent “Code Red” containing DMAA, resolving rapidly with stopping the supplement and interpreted as rhabdomyolysis due to DMAA).
Schreiner NM, Windham S, Barker A. (2017). Atypical neuroleptic malignant syndrome: diagnosis and proposal for an expanded treatment algorithm: a case report. A A Case Rep. (48 year old man with bipolar disorder and NASH underwent liver transplantation and developed confusion, dyskinesia, rigidity, hyperthermia and tachycardia/tachypnea postoperatively having been given lithium, lamotrigine, promethazine and ziprasidone, responding to therapy of neuroleptic malignant syndrome with benzodiazepines and propofol).
Baeza I, de la Serna E, Calvo-Escalona R, Merchán-Naranjo J, Rodríguez-Latorre P, Martínez-Cantarero MC, Andrés P, et al. (2018). One-year prospective study of liver function tests in children and adolescents on second-generation antipsychotics: is there a link with metabolic syndrome?. J Child Adolesc Psychopharmacol. (Among 216 children and adolescents starting atypical antipsychotics, mean weight gain at 6 months was 6.5 kg and mean ALT levels increased by 8.6 U/L, while among 37 taking olanzapine mean weight gain was 10.3 kg and ALT increase 2.6 U/L; increases in ALT associated with development of the metabolic syndrome, mean ALT increasing by 27.8 U/L at 6 months; results using ziprasidone not included).
Girard TD, Exline MC, Carson SS, Hough CL, Rock P, Gong MN, Douglas IS, et al. (2018). MIND-USA Investigators. Haloperidol and ziprasidone for treatment of delirium in critical illness. N Engl J Med. (Among 566 adults who developed delirium during therapy for respiratory failure or shock and were treated with ziprasidone [maximum dose 40 mg daily], haloperidol [maximum dose 20 mg daily], or placebo, duration of delirium and major outcomes were similar in the three groups; no mention of ALT elevations or hepatotoxicity but QTc prolongation was more frequent with ziprasidone).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%] and risperidone [27 of 51,683: 0.05%]; two fatal cases occurred in olanzapine-treated patients; low rates were found for ziprasidone [no cases among 3568 patients treated] and aripiprazole [6 cases of 15,988 patients treated: 0.01%).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine, but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).
Atkinson S, Bachinsky M, Raiter Y, Abreu P, Ianos C, Chappell P, Findling RL. (2022). 26-Week open-label extension study evaluating the safety and tolerability of flexible doses of oral ziprasidone in children and adolescents with bipolar I disorder (Most Recent Episode Manic). J Child Adolesc Psychopharmacol. (Among 23 adolescents treated with ziprasidone in a 4 week controlled trial who were started or continued on therapy for up to 26 weeks, side effects included fatigue, somnolence, nausea and extrapyramidal symptoms, usually transiently shortly after starting; no mention of ALT levels or hepatotoxicity).
Gunther M, Dopheide JA. (2023). Antipsychotic safety in liver disease: a narrative review and practical guide for the clinician. J Acad Consult Liaison Psychiatry. (Review of the literature on hepatotoxicity of antipsychotic medications and guidance on their use in patients with liver disease characterizes chlorpromazine, clozapine, and olanzapine as having the greatest risk for causing liver injury, quetiapine and risperidone as having moderate risk, haloperidol as having low risk and paliperidone, aripiprazole, lurasidone, loxapine, and ziprasidone as having low risk).

## OTHER REFERENCE LINKS

1 Recent References on Ziprasidone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ziprasidone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ziprasidone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ziprasidone)